# Vosoritide

## OVERVIEW

### Introduction

Vosoritide is a modified recombinant C type natriuretic peptide analog which is used to promote linear growth in children and adolescents with achondroplasia who still have open epiphyses. Vosoritide is given in daily subcutaneous injections and its use has not been associated with elevations in serum aminotransferase levels or with cases of clinically apparent liver injury.

### Background

Vosoritide (voe’ soe re’ i tide) is a modified, recombinant 39 amino acid analogue of human C type natriuretic peptide which is used to increase linear growth in children and adolescents with achondroplasia. Achondroplasia is a rare (1:25,000 live births) autosomal dominant genetic disease marked by impaired conversion of cartilage to bone resulting in short stature and in skeletal abnormalities of long bones, spine, face and skull. Achondroplasia is due to gain-of-function mutations in fibroblast growth factor receptor 3 (FGFR3), a negative regulator of bone growth and endochondral ossification. Affected individuals have short limbs but fairly normal truncal size and resultant skeletal abnormalities that affect cranial, musculoskeletal, cardiovascular, ear, nose and throat structure and function. Human type C natriuretic peptide acts as an antagonist to the downstream signaling of FGFR3. In animal models of achondroplasia, treatment with vosoritide led to increases in linear growth and improvement in endochondral ossification, ameliorating the structural abnormalities and secondary consequences of the excessive FGFR3 signaling. In a single, randomized controlled trial in 121 pediatric patients (ages 5 to 14) with achondroplasia, vosoritide given by injection daily for 52 weeks led to a significant increase in annualized growth velocity. All subjects were then treated with open label vosoritide and evaluated for its long term effects. Vosoritide was granted accelerated approval for use in the United States in 2021. Current indications are for pediatric patients with achondroplasia with open epiphyses. Vosoritide is available under the brand name Voxzogo as a lyophilized powder for reconstitution in 0.40, 0.56 and 1.2 mg amounts in single dose vials. The recommended dose is based upon weight at approximately 15 mcg/kg given subcutaneously once daily, with monitoring of weight and appropriate adjustment of dose and stopping once epiphyses are closed. Vosoritide relaxes vascular muscle and can cause mild hypotension. Other adverse events include injection site reactions (erythema, swelling, rash, urticaria), nausea, vomiting, diarrhea, gastroenteritis, ear pain and arthralgia. The long- term effects on bone growth and structure are still being assessed in prospective studies, but improved rates of linear growth appear to be maintained.

### Hepatotoxicity

In the registration studies submitted in support of approval of vosoritide, “overall, there were no clinically meaningful changes in any laboratory parameter in the clinical program.” Serum ALT levels rose to above the upper limit of normal (ULN) in 22% of vosoritide treated participants vs 18% of controls, but there were no increases above 5 times ULN or elevations accompanied by jaundice or symptoms. Alkaline phosphatase elevations arose in at least 17% of treated patients vs 7% of controls, but the abnormalities were possibly a result of bone growth rather than liver or biliary injury. In the initial clinical trial and in subsequent more widespread use of vosoritide, there have been no reports of clinically apparent liver injury or jaundice.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which vosoritide might cause liver injury is unknown. It is a polypeptide and is metabolized to individual amino acids intracellularly in many tissues. Vosoritide is not metabolized by the cytochrome P450 system and has not been associated with drug-drug interactions.

### Outcome and Management

Vosoritide has not been implicated in marked serum aminotransferase elevations or instances of acute liver injury. While minor elevations in serum enzymes may occur during therapy, these are generally transient, asymptomatic, and most likely unrelated to treatment.

Drug Class: Genetic Disorder Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vosoritide – Voxzogo®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vosoritide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Vosoritide | 1480724-61-5 | C176-H290-N56-O51-S3

## BIBLIOGRAPHY

References updated: 31 January 2025

Zimmerman HJ. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert textbook on hepatotoxicity published in 1999, before the availability of vosoritide).
Nolin TD, Friedman PA. Agents affecting mineral ion homeostasis and bone turnover. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 887-906. (Textbook of pharmacology and therapeutics).
FDA. Integrated Review. 2021. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/214938Orig1s000IntegratedR.pdf (FDA website with product labels and integrated review of the data on efficacy and safety submitted by the sponsor in support of approval in the US, mentions that “overall, there were no clinically meaningful changes in any laboratory parameter in the clinical program” and that elevations in ALT arose in 22% of vosoritide vs 18% of placebo recipients, AST in 10% vs 7%, and alkaline phosphatase in 17% vs 7%).
Lorget F, Kaci N, Peng J, Benoist-Lasselin C, Mugniery E, Oppeneer T, Wendt DJ, et al. Evaluation of the therapeutic potential of a CNP analog in a Fgfr3 mouse model recapitulating achondroplasia. Am J Hum Genet. 2012;91:1108-14. (A synthetic 39 amino acid analogue of C-type natriuretic peptide, with modifications allowing for longer half-life, improved bone growth and clinical features of achondroplasia in a mouse model). 23200862
Savarirayan R, Irving M, Bacino CA, Bostwick B, Charrow J, Cormier-Daire V, Le Quan Sang KH, et al. C-type natriuretic peptide analogue therapy in children with achondroplasia. N Engl J Med. 2019;381:25-35. (Among 35 children with achondroplasia, ages 5 to 14 years, treated with once daily sc injections of vosoritide in 4 dose regimens for 6 months and then with the optimal dose for up to 42 months, there was a dose-dependent increase in annualized growth velocity and adverse events were “generally mild”; no mention of ALT elevations or hepatotoxicity). 31269546
Savarirayan R, Tofts L, Irving M, Wilcox W, Bacino CA, Hoover-Fong J, Ullot Font Ret al. Once-daily, subcutaneous vosoritide therapy in children with achondroplasia: a randomised, double-blind, phase 3, placebo-controlled, multicentre trial. Lancet. 2020;396(10252):684-692. (Among 121 children, ages 5 to 18 years, with achondroplasia and open epiphyses treated with vosoritide [15 µg/kg] vs placebo sc once daily for 52 weeks, the mean change in annualized growth velocity was 1.71 vs 0.13 cm/year while adverse events arose in similar rates in both groups [98% vs 98%], with injection site reactions and mild hypotension being more frequent with vosoritide; no mention of ALT elevations or hepatotoxicity). 32891212
Duggan S. Vosoritide: first approval. Drugs. 2021;81:2057-2062. (Review of the mechanism of action, history of development, clinical efficacy, and safety of vosoritide, mentions that it was well tolerated in registration trials and in long term extension studies, the major adverse event being injection reactions; no mention of ALT elevations or hepatotoxicity). 34694597
Schneider EL, Carreras CW, Reid R, Ashley GW, Santi DV. A long-acting C-natriuretic peptide for achondroplasia. Proc Natl Acad Sci U S A. 2022;119:e2201067119. (A modified analogue of human C type natriuretic peptide conjugated to polyethylene glycol gel proved to have a long half-life and was effective in a mouse model of achondroplasia given every 1 or 2 weeks.) 35858423
Savarirayan R, Wilcox WR, Harmatz P, Phillips J 3rd, Polgreen LE, Tofts L, Ozono K, et al. Vosoritide therapy in children with achondroplasia aged 3-59 months: a multinational, randomised, double-blind, placebo-controlled, phase 2 trial. Lancet Child Adolesc Health. 2024;8:40-50. (Among 32 children with achondroplasia below the age of 5 years treated with daily injections of vosoritide [15 or 30 μg/kg] or placebo for 52 weeks, annualized growth velocity varied by age and was higher with vosoritide therapy, while adverse events were frequent but most often mild injection site reactions; no mention of ALT levels or hepatotoxicity). 37984383
Savarirayan R, Irving M, Wilcox WR, Bacino CA, Hoover-Fong JE, Harmatz P, Polgreen LE, et al. Sustained growth-promoting effects of vosoritide in children with achondroplasia from an ongoing phase 3 extension study. Med. 2024 Dec 30:100566. Epub ahead of print. (Among 119 children with achondroplasia enrolled in a controlled trial of vosoritide [Savarirayan 2019] and subsequently in an extension study, 111 have continued in the study with follow up of 1.7 to 6.2 years, maintaining a higher annualized growth velocity than in untreated patients and similar velocity to that of average normal children; no mention of ALT elevations or hepatotoxicity). 39740666
Cormier-Daire V, Edouard T, Isidor B, Mukherjee S, Pimenta JM, Rossi M, Schaefer E, et al. Real-world safety and effectiveness of vosoritide in children with achondroplasia: French early access program. Horm Res Paediatr. 2025:1-17. Epub ahead of print. (Among 62 children with achondroplasia enrolled in an early access program for therapy with vosoritide in France, 22 received drug for 12 months and achieved an average annualized growth velocity of 6.0 cm with mild adverse events only, and no discontinuations for adverse events; no mention of ALT elevations or hepatotoxicity). 39864410

## OTHER REFERENCE LINKS

1. Recent References on Vosoritide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Vosoritide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Vosoritide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vosoritide)